# Arnica Montana

## OVERVIEW

### Introduction

Arnica montana, also known as wolf’s bane, is an herbal medication used topically for pain and inflammation but is of unproven efficacy. It is an extract of the flowering plant Arnica montana, a member of the daisy family. Arnica montana is used topically and as such has not been linked to serum aminotransferase elevations or to clinically apparent liver injury.

### Background

Arnica montana (also called wolf’s bane) is a tall perineal plant with large yellow flowers that belongs to the daisy family Asteraceae and is widespread across Europe. Arnica montana is used in small oral doses in homeopathic medicine and in low doses as treatment for pain, inflammation and fever, most often post-surgery or trauma. It is also used more conventionally as a topical medication for wound healing, swelling, inflammation, bruising and pain. However, there is little evidence for its efficacy either as an oral homeopathic or a topical herbal therapy. The FDA classifies Arnica montana as an unsafe herb and cautions against using it orally or applied to broken skin where absorption can occur. Arnica montana extracts have antiinflammatory effects in vitro and have been purported to be beneficial for pain and swelling when applied topically. The clinical studies have not confirmed its effects on inflammation or pain. Arnica montana is available in multiple over-the-counter topical forms which are claimed to be useful in treating painful skin conditions. Arnica montana extracts applied topically have mild-to-moderate adverse events, which usually overwhelm any beneficial effects they may have on skin conditions. Oral administration of Arnica montana in moderate amounts can cause gastrointestinal upset, nausea, vomiting and abdominal pain. Arnica montana extracts can cause skin rash and urticaria and should not be taken by mouth.

### Hepatotoxicity

In multiple small, rather short term clinical trials of different preparations of Arnica montana extracts, adverse side effects were described as uncommon and local with no mention of either hepatotoxicity or ALT elevations. Despite widespread use, there have been no published reports of serum enzyme elevations or clinically apparent liver injury attributable to either homeopathic low doses orally or conventional topically applied Arnica montana extracts.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which Arnica montana might cause liver injury is unknown.

### Outcome and Management

Hepatotoxicity from topically applied extracts of Arnica montana has not been reported.

Drug Class: Herbal and Dietary Supplements

Other names: Arnica, Wolf’s bane, Leopard’s bane, Mountain tobacco.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Arnica montana – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at MedlinePlus, NLM (https://medlineplus.gov/druginfo/natural/721.html)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Arnica montana | 68990-11-4 (https://pubchem.ncbi.nlm.nih.gov/substance/135320196) | Herbal | Not Applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 03 March 2023

Abbreviations: HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not Arnica montana).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements [HDS] published in 2007; no mention of Arnica montana).
Arnica montana. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 43-47. (Compilation of short monographs on herbal medications and dietary supplements).
Hörmann HP, Korting HC. (1994). Evidence for the efficacy and safety of topical herbal drugs in dermatology: Part I: Anti-inflammatory agents. Phytomedicine. (Review of the efficacy and safety of topically applied herbal products used to treat skin diseases mentions that data on the clinical efficacy of topical Arnica montana “are virtually absent”, while there have been at least 35 publications on toxic or allergic skin reactions due to the herbal product perhaps due to sensitizing sesquiterpene lactones).
Hart O, Mullee MA, Lewith G, Miller J. (1997). Double-blind, placebo-controlled, randomized clinical trial of homoeopathic arnica C30 for pain and infection after total abdominal hysterectomy. J R Soc Med. (Among 73 women undergoing abdominal hysterectomy treated with homeopathic doses of Arnica montana or placebo the day before and then for 5 days after surgery, need for antibiotics and analgesics, duration of hospitalization, and serial daily pain scores were similar in the two groups; no mention of side effects, ALT elevations or hepatotoxicity).
Ernst E, Pittler MH. (1998). Efficacy of homeopathic arnica: a systematic review of placebo-controlled clinical trials. Arch Surg. (Among 8 published, controlled trials of homeopathic Arnica montana for trauma, muscular soreness, bruising or postoperative pain and complications, most studies had major methodological flaws, limited or no statistical testing, and minimal and clinically insignificant degrees of benefit; no discussion of side effects).
Vickers AJ, Fisher P, Smith C, Wyllie SE, Rees R. (1998). Homeopathic Arnica 30x is ineffective for muscle soreness after long-distance running: a randomized, double-blind, placebo-controlled trial. Clin J Pain. (Among 400 long distance runners treated with Arnica montana [1:1000 dilution] or placebo the night before and twice daily for 5 days after a race [usually 6 to 26 miles], muscle soreness was similar in the two groups as measured by visual analog scales and adverse event rates were similar as well).
Tveiten D, Bruset S. (2003). Effect of Arnica D30 in marathon runners. Pooled results from two double-blind placebo controlled studies. Homeopathy. (Among 82 Oslo city marathon runners treated with Arnica vs placebo twice daily for 5 days starting the evening before the race, muscle soreness symptom scores were less in those receiving Arnica, while serum enzymes rose to a similar extent in both groups from before to 42 to 64 hours afterwards [in placebo group, mean ALT rose from 20 to 33 and 36, AST from 21 to 70 to 54 U/L, CK from 152 to 1180 and 590 U/L]).
Wolf M, Tamaschke C, Mayer W, Heger M. (2003). Forsch Komplementarmed Klass Naturheilkd. (Among 60 patients undergoing surgery for varicose veins treated with either Arnica montana or placebo, pain scores and improvement in size of hematomas were not significantly different in the two groups, but both therapies were well tolerated with no serious adverse events; no mention of ALT elevations or hepatotoxicity).
Stevinson C, Devaraj VS, Fountain-Barber A, Hawkins S, Ernst E. (2003). Homeopathic arnica for prevention of pain and bruising: randomized placebo-controlled trial in hand surgery. J R Soc Med. (Among 64 adults treated with one of two doses of Arnica montana or placebo tablets daily for 7 days before and for 14 days after surgery for carpal tunnel syndrome, there were no differences in measures of pain, swelling or bruising or in use of analgesic medications in the two groups; adverse events rates were also similar in the two groups and were generally mild with no mention of ALT elevations or hepatotoxicity).
Ernst E. (2003). The benefits of Arnica: 16 case reports. Homeopathy. (Listing of letters describing 16 cases with beneficial effects from Arnica montana therapy for trauma, surgery, pain, bruising and inflammation, all of which the author claims could have occurred by chance or be due to other factors).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry found two cases of contact dermatitis, but no instances of liver or other organ injury attributed to Arnica montana).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements, but does not list or mention Arnica montana).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury does not mention Arnica montana).
Navarro VJ, Seeff LB. (2013). Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal and traditional herbal remedies).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products, but no case was attributed specifically to Arnica montana).
Iannitti T, Morales-Medina JC, Bellavite P, Rottigni V, Palmieri B. (2016). Effectiveness and safety of Arnica montana in post-surgical setting, pain and inflammation. Am J Ther. (Review of the mechanism of action, clinical efficacy and safety of Arnica montana, both orally in low doses and topically, concludes that topical Arnica is well tolerated and oral formulations are safe, but only when given in low [homeopathic] doses; no mention of liver related adverse events).
Brown AC. (2017). Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol. (Description of an online compendium of cases of liver toxicity attributed to HDS products, does not list or discuss Arnica montana).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al., Spanish DILI Registry. (2018). Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], no mention of Arnica montana).
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. (2021). Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48]; Arnica montana is not discussed).
Sherban A, Wang JV, Geronemus RG. (2021). Growing role for arnica in cosmetic dermatology: Lose the bruise. J Cosmet Dermatol. (Review of published clinical trials of oral and topical Arnica montana in reducing pain, redness, edema and ecchymoses after cosmetic dermatology concludes that while some studies have been promising, there does not seem to be definitive or consistent evidence supporting its efficacy and safety, major hurdles being the lack of information on purity, potency and dose of the herbal product).
Thakur JH, Katre AN. (2022). Comparison of the efficacy of homeopathic drug Arnica and ibuprofen on postextraction pain in children: a triple-blind randomized controlled trial. Int J Clin Pediatr Dent. (Among 44 children, ages 8 to 12, undergoing two session of tooth extraction were treated with either Arnica montana or ibuprofen [dose and route of administration not provided] 3 times daily for 3 days in a cross over design, pain reduction was greater with ibuprofen, but children preferred the taste of Arnica montana; no mention of adverse events).
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. (2022). Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while Arnica montana is not mentioned).

## OTHER REFERENCE LINKS

1 Recent References on Arnica montana: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Arnica+montana+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Arnica montana: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Arnica%20montana)